# Gemfibrozil

## OVERVIEW

### Introduction

Gemfibrozil is a fibric acid derivative used in the therapy of hypertriglyceridemia and dyslipidemia. Gemfibrozil therapy is associated with mild and transient serum aminotransferase elevations and with rare instances of acute liver injury.

### Background

Gemfibrozil (jem fye' broe zil) is a fibric acid derivative and lipid lowering agent. The lipid lowering activity of gemfibrozil is probably mediated by its interactions with the peroxisome proliferator activated receptor alpha (PPARα), which regulates gene expression of enzymes involved in fatty acid oxidation. Gemfibrozil increases lipoprotein lipase levels, which enhance clearance of triglyceride rich lipoproteins. Gemfibrozil was approved for use in the United States in 1981 and it is still widely used with more than 5 million prescritions filled yearly. Gemfibrozil is recommended for therapy of hypertriglyceridemia (Fredrickson type IV and V hyperlipidemia) and hypercholesterolemia (type IIb). Gemfibrozil therapy has been shown to lower rates of myocardial infarction and stroke, most likely as a result of its effects on HDL cholesterol and triglyceride levels. Gemfibrozil is available in multiple generic forms and under the brand name of Lopid as tablets of 600 mg. The recommended dosage is 600 mg twice daily before morning and evening meals. Common side effects of gemfibrozil include gastrointestinal upset, diarrhea, constipation and fatigue. Fibrates have multiple drug interactions requiring careful review and use.

### Hepatotoxicity

Mild, transient serum aminotransferase elevations develop in approximately 20% of patients receiving gemfibrozil, but values above 3 times normal in 5% or less. These abnormalities are usually asymptomatic and transient, resolving even with continuation. However, there have also been rare reports of clinically apparent liver injury in patients on long term gemfibrozil. The clinical presentation was highly variable. The onset of injury varied from a few weeks to several years after starting the medication and the pattern of serum enzyme elevations ranged from hepatocellular (Case 1) to mixed to cholestatic. Cases have not been associated with signs of immunoallergic (fever, rash, eosinophilia) or autoimmune hepatitis and recovery has been prompt and complete with stopping therapy.

Likelihood score: C (probable rare cause of clinically apparent liver injury).

### Mechanism of Injury

The mechanism of hepatotoxicity of the gemfibrozil is not known, but is likely due to an immunologic response to an intermediate of its metabolism.

### Outcome and Management

The few published instances of clinically apparent hepatotoxicity due to gemfibrozil have been mild and self-limited. There have been no published reports of acute liver failure, chronic hepatitis or vanishing bile duct syndrome related to gemfibrozil. It is unclear whether liver injury is a class effect of the fibrates. There is little evidence for cross sensitivity to hepatotoxicity among the various fibrates.

Drug Class: Antilipemic Agents, Fibrates

## CASE REPORT

### Case 1. Mild acute hepatitis due to gemfibrozil.

[Modified from: Domínguez Tordera P, Comellas Alabern JF, Ronda Rivero F. Gemfibrozil hepatotoxicity: a case report. Int J Clin Pharm 2011; 33: 730-2. PubMed Citation (https://www.ncbi.nlm.nih.gov/pubmed/21881934)]

A 55 year old woman developed nausea and fatigue one month after starting gemfibrozil (600 mg daily). Several months before this she had been involved in a motor vehicle accident and was admitted to the hospital for management of thoracic and ankle trauma. At that time, all liver tests were normal and an ultrasound of the abdomen (done to assess trauma) showed small gallstones, but no abnormalities of intra- or extra-hepatic bile ducts. She was treated for trauma and fractures and was started on enoxaparin, esomeprazole, venlafaxine and metamizol (an analgesic and antipyretic not available in the United States). During follow up after the admission, she was found to have hypertriglyceridemia (239 mg/dL), but normal cholesterol levels and was started on gemfibrozil, which she had not taken previously. She had no history of liver disease, alcohol use, or known risk factors for viral hepatitis. She denied rash, fever and abdominal pain. Blood tests at the time of onset of fatigue showed marked elevations in serum aminotransferase levels (ALT 1142 U/L, AST 656 U/L), modest increase in alkaline phosphatase (331 U/L) and GGT (420 U/L), and a total serum bilirubin of 2.7 mg/dL (2.2 mg/dL direct). Tests for hepatitis A, B and C were negative. Tests for autoantibodies were not mentioned. Abdominal ultrasound showed the previously described gallstones, but no evidence of biliary obstruction. Gemfibrozil was discontinued, but her other medications were not. Serum enzyme abnormalities rapidly improved and were largely normal 2 weeks later (Table).

#### Key Points

Medication: | Gemfibrozil (600 mg daily)
Pattern: | Hepatocellular (R=12.4)
Severity: | 2+ (mild jaundice)
Latency: | 1 month
Recovery: | 2 months
Other medications: | Enoxaparin, esomeprazole, venlafaxine, metamizol

#### Laboratory Values

Time After Starting | Time After Stopping | ALT (U/L) | Alk P (U/L) | Bilirubin (mg/dL) | Other
- 2 months | Pre | Normal | Normal | Normal | Admission for trauma
0 | Pre | Started on gemfibrozil (600 mg daily)
4 weeks | 0 | 1142 | 331 | 2.7 | Gemfibrozil stopped
| 2 days | 550 | 249 | | Symptoms improved
5 weeks | 2 weeks | 30 | 141 | 0.4
Normal Values | | <40 | <126 | <1.2

#### Comment

Acute hepatocellular injury arose within a month of starting gemfibrozil therapy. The patient was taking several other drugs that might cause liver injury (enoxaparin, venlafaxine and even esomeprazole), but these were continued and only the gemfirbrozil was held. She improved rapidly which was evident within 2 days and nearly complete within 2 weeks. The acute hepatocellular injury with mild jaundice and rapid recovery (<1 month) on stopping the drug are typical of gemfibrozil induced liver injury.

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Gemfibrozil – Generic, Lopid®

DRUG CLASS

Antilipemic Agents

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=gemfibrozil)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NUMBER | MOLECULAR FORMULA | STRUCTURE
Gemfibrozil | 25812-30-0 | C15-H22-O3 | Image of Chemical Structure

## ANNOTATED BIBLIOGRAPHY

References updated: 24 January 2017

Zimmerman HJ. Drugs used in the treatment of hypercholesterolemia and hyperlipidemia. In, Zimmerman HJ. Hepatotoxicity: the adverse effects of drugs and other chemicals on the liver. 2nd ed. Philadelphia: Lippincott, 1999, pp. 660-2. (Expert review of hepatotoxicity of lipid lowering agents including clofibrate, fenofibrate and gemfibrozil, all three of which can lead to mild-to-moderate serum aminotransferase elevations, and which have been associated with rare instances of clinically apparent hepatic injury).
De Maurzio DH, Navarro VJ. Fibrates. Hepatotoxicity of cardiovascular and antidiabetic drugs. In, Kaplowitz N, DeLeve LD, eds. Drug-induced liver disease. 3rd ed. Amsterdam: Elsevier, 2013, pp. 527. (Review of hepatotoxicity of fibrates; transient ALT or AST elevations during therapy are common and rare instances of acute and chronic hepatic injury due to fibrates have been reported, with variable patterns of injury and times of onset).
Bersot TP. Drug therapy for hypercholesterolemia and dyslipidemia. In, Brunton LL, Chabner BA, Knollman BC, eds. Goodman & Gilman’s the pharmacological basis of therapeutics. 12th ed. New York: McGraw-Hill, 2011, pp. 877-908. (Textbook of pharmacology and therapeutics).
De La Iglesia FA, Lewis JE, Buchanan AR, Marcus EL, McMahon G. Light and electron microscopy in hyperlipoproteinemic patients under long-term gemfibrozil treatment. Atherosclerosis 1982; 43: 19-37. PubMed Citation (https://www.ncbi.nlm.nih.gov/pubmed/%206807326) (Detailed analysis of light and electron microscopic changes in liver biopsies from 9 patients without liver test abnormalities on successful long term [18-27 months] therapy with gemfibrozil; mild fatty change was found, but there was minimal to no abnormalities of peroxisomes and mitochondria such as have been reported in rodents given gemfibrozil).
Pickering JE. Clinical results with gemfibrozil. Am J Cardiol 1983; 52: 39B-40B. (Review of clinical trials of gemfibrozil; most common side effects were gastrointestinal upset and liver test abnormalities occurred in <3% of patients: Abstract only). 6351579
Frick MH, Elo O, Haapa K, Heinonen OP, Heinsalmi P, Helo P, Huttunen JK, et al. Helsinki Heart Study: primary-prevention trial with gemfibrozil in middle-aged men with dyslipidemia. Safety of treatment, changes in risk factors, and incidence of coronary heart disease. N Engl J Med 1987; 317: 1237-45. (In a controlled trial of gemfibrozil vs placebo for up to 5 years in 4081 men with dyslipidemia, "no differences between the two treatment groups were observed in...laboratory multichannel analyses"). 3313041
Athyros VG, Athyros VG, Papageorgiou AA, Hatzikonstandinou HA, Didangelos TP, Carina MV, Kranitsas DF, et al. Safety and efficacy of long-term statin-fibrate combinations in patients with refractory familial combined hyperlipidemia. Am J Cardiol 1997; 80: 608-13. (389 patients treated with statin and fibrate combination for average of 2.5 years; 1.3% stopped because of ALT above 3 times normal, all resolving within 4 weeks; no hepatitis or jaundice reported). 9294990
Frick MH, Syvänne M, Nieminen MS, Kauma H, Majahalme S, Virtanen V, Kesäniemi YA, et al. Prevention of the angiographic progression of coronary and vein-graft atherosclerosis by gemfibrozil after coronary bypass surgery in men with low levels of HDL cholesterol. Lopid Coronary Angiography Trial (LOCAT) Study Group. Circulation 1997; 96: 2137-43. (Controlled trial of gemfibrozil vs placebo in 395 men after coronary bypass surgery; "significant" liver enzyme elevations occurred in 9 gemfibrozil [5%], but no placebo recipient; no details provided). 9337181
Rubins HB, Robins SJ, Collins D, Fye CL, Anderson JW, Elam MB, Faas FH, et al. Gemfibrozil for the secondary prevention of coronary heart disease in men with low levels of high-density lipoprotein cholesterol. Veterans Affairs High-Density Lipoprotein Cholesterol Intervention Trial Study Group. N Engl J Med 1999; 341: 410-8. (Controlled trial of gemfibrozil vs placebo for an average of 5 years in 2531 men with coronary artery disease, the numbers of patients with AST elevations "did not differ significantly between the groups"). 10438259
Bustamante Balén M, Plumé Gimeno G, Bau González I, Berenguer Lapuerta J. Acute hepatitis caused by gemfibrozil. Gastroenterol Hepatol 1998; 21: 419-20. (69 year old woman developed dark urine after 2 years of therapy with gemfibrozil [bilirubin 3.1 mg/dL, ALT 1931 U/L], falling to normal within one month of stopping). 9844285
de Diego Lorenzo A, Catalina V, García Sánchez A, Escudero M, Cos E, Clemente G. Cholestatic hepatitis caused by gemfibrozil. Rev Esp Enferm Dig 2001; 93; 610-1. (67 year old man developed jaundice 2 years after starting gemfibrozil [bilirubin 8.2 mg/dL, ALT 524 U/L, Alk P 551 U/L], resolving rapidly with stopping drug). 11767440
Alsheikh-Ali AA, Kuvin JT, Karas RH. Risk of adverse events with fibrates. Am J Cardiol 2004; 94: 935-8. (Review of adverse event reports to FDA for gemfibrozil and fenofibrate from 1999-2003; hepatotoxicity report rates were 13 per million for gemfibrozil vs 14.6 per million for fenofibrate). 15464682
Grubisić-Cabo F, Vrdoljak E. Drug-induced hepatitis in a patient with malignant melanoma treated with interferon alfa 2b adjuvantly who had been administered gemfibrozil in therapy. Med Oncol 2006; 23: 121-4. (61 year old with melanoma was treated with interferon alfa [15 mu thrice weekly] for 3 months and then developed rises in ALT [34 to 708 U/L] and bilirubin [0.7 to 1.3 mg/dL] within a few weeks of starting gemfibrozil, resolving within a few weeks of stopping both). 16645237
Andrade RJ, Lucena MI, Fernández MC, Pelaez G, Pachkoria K, García-Ruiz E, García-Muñoz B, et al.; Spanish Group for the Study of Drug-Induced Liver Disease. Drug-induced liver injury: an analysis of 461 incidences submitted to the Spanish registry over a 10-year period. Gastroenterology 2005; 129: 512-21. (Analysis of 461 cases of drug induced liver disease 1984 to 2004 in Spanish Registry; 4 cases were attributed to fibrates). 16083708
Andrade RJ, Lucena MI, Kaplowitz N, García-Muņoz B, Borraz Y, Pachkoria K, García-Cortés M, et al. Outcome of acute idiosyncratic drug-induced liver injury: Long-term follow-up in a hepatotoxicity registry. Hepatology 2006; 44: 1581-8. (28 of 493 [5.7%] cases of drug induced liver disease were found to have evidence of chronic injury; 2 chronic cholestatic cases were attributed, at least in part, to fibrates; gemfibrozil/lovastatin and fenofibrate/raloxifen). 17133470
Akoglu H, Yilmaz R, Kirkpantur A, Arici M Altun B, Turgan C. Combined organ failure with combination antihyperlipidemic treatment: a case of hepatic injury and acute renal failure. Ann Pharmacother 2007; 41: 143-7. (56 year old woman developed fatigue and red urine 1 month after starting combination of fluvastatin and gemfibrozil [bilirubin normal, ALT 2100 U/L, Alk P normal, creatinine 1.8 mg/dL, CPK 45,758 U/L, and myoglobin >3000 ng/dL], resolving rapidly upon stopping both drugs). 17148651
Chalasani N, Fontana RJ, Bonkovsky HL, Watkins PB, Davern T, Serrano J, Yang H, Rochon J; Drug Induced Liver Injury Network (DILIN). Causes, clinical features, and outcomes from a prospective study of drug-induced liver injury in the United States. Gastroenterology 2008; 135: 1924-34. (Among 300 cases of drug induced liver disease in the US collected from 2004 to 2008, 1 case attributed to fenofibrate; none to clofibrate or gemfibrozil). 18955056
Domínguez Tordera P, Comellas Alabern JF, Ronda Rivero F. Gemfibrozil hepatotoxicity: a case report. Int J Clin Pharm 2011; 33: 730-2. (55 year old woman developed fatigue 1 month after starting gemfibrozil for hypertriglyceridemia [bilirubin 2.7 mg/dL, ALT 1142 U/L, Alk P 331 U/L], resolving within 2 weeks of stopping: Case 1). 21881934
Reuben A, Koch DG, Lee WM; Acute Liver Failure Study Group. Drug-induced acute liver failure: results of a U.S. multicenter, prospective study. Hepatology 2010; 52: 2065-76. (Among 1198 patients with acute liver failure enrolled in a US prospective study between 1998 and 2007, 133 were attributed to drug induced liver injury, but none were attributed to a fibrate). 20949552
Björnsson ES, Bergmann OM, Björnsson HK, Kvaran RB, Olafsson S. Incidence, presentation and outcomes in patients with drug-induced liver injury in the general population of Iceland. Gastroenterology 2013; 144: 1419-25. (In a population based study of drug induced liver injury from Iceland, 96 cases were identified over a 2 year period, but none were attributed to a fibrate). 23419359
Hernández N, Bessone F, Sánchez A, di Pace M, Brahm J, Zapata R, A Chirino R, et al. Profile of idiosyncratic drug induced liver injury in Latin America. An analysis of published reports. Ann Hepatol 2014; 13: 231-9. (Systematic review of literature on drug induced liver injury in Latin American countries published from 1996 to 2012 identified 176 cases, none of which were attributed to a fibrate). 24552865
Chalasani N, Bonkovsky HL, Fontana R, Lee W, Stolz A, Talwalkar J, Reddy KR, et al.; United States Drug Induced Liver Injury Network. Features and outcomes of 899 patients with drug-induced liver injury: The DILIN Prospective Study. Gastroenterology 2015; 148: 1340-52.e7. (Among 899 cases of drug induced liver injury enrolled in a US prospective study between 2004 and 2013, 4 cases [0.5%] were attributed to fibrates, all to fenofibrate). 25754159

## OTHER REFERENCE LINKS

1. Recent References on Gemfibrozil: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=gemfibrozil+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D%3A%222999/12/31%22%5BEDat%5D))
2. Trials on Gemfibrozil: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=gemfibrozil)